# Neomycin

## OVERVIEW

### Introduction

Neomycin is a broad spectrum aminoglycoside antibiotic whose current use is limited to oral and topical administration. Neomycin has minimal oral absorption and its use has not been linked to instances of acute liver injury.

### Background

Neomycin (nee" oh mye' sin) is an aminoglycoside with a broad spectrum of activity against both gram positive and gram negative organisms. Like other aminoglycosides, neomycin is thought to act by binding to bacterial ribosomes and inhibiting protein synthesis. Neomycin has activity against many aerobic gram negative and gram positive bacteria, including the major E. coli species resident in the colon as well as the enteropathogenic forms of E. coli known to cause traveler’s diarrhea. Like other aminoglycosides, neomycin is poorly absorbed orally. The lack of absorption from the gastrointestinal tract is the basis of the main use of neomycin, as an oral agent to suppress intestinal bacterial flora. Oral neomycin is indicated for treatment of infectious diarrhea, for suppression of intestinal bacterial flora in patients undergoing colorectal surgery, and as a means of decreasing colonic bacteria and production of ammonia in hepatic encephalopathy. Topical neomycin is used for burns, wounds and ulcerations and as otic suspensions for external otitis. Neomycin is available in multiple generic forms including oral tablets of 500 mg. The typical adult dose of neomycin is 1 to 3 grams daily in four divided doses. Long term therapy should be avoided because of the possibility of some systemic absorption and the high rate of oto- and nephrotoxicity associated with neomycin use. Other adverse events include nausea, diarrhea, and Clostridium difficile related colitis.

### Hepatotoxicity

Oral and topical therapy with neomycin has not been linked serum alkaline phosphatase or aminotransferase elevations, and no convincing cases of symptomatic or icteric hepatotoxicity due to oral neomycin have been published. The poor absorption of neomycin makes it unlikely that systemic levels of the drug that might cause liver injury could be achieved. Furthermore, the ototoxicity of absorbed neomycin is likely to supervene before liver toxicity would occur.

References to the safety and potential hepatotoxicity of neomycin are provided in the Overview section on the Aminoglycosides.

Drug Class: Aminoglycosides

Other Drugs in the Class: Amikacin, Gentamicin, Plazomicin, Streptomycin, Tobramycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Neomycin – Generic

DRUG CLASS

Aminoglycosides

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Neomycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Neomycin | 1404-04-2 | Unspecified | Neomycin chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Neomycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=neomycin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Neomycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=neomycin)